# Anticonvulsants

## OVERVIEW

Anticonvulsant medications include many agents that have been incriminated in causing idiosyncratic drug induced liver disease. Indeed, several commonly used anticonvulsants (phenytoin, valproate, carbamazepine) are consistently ranked in the top causes of clinically apparent drug induced liver injury and are frequently listed in causes of drug induced acute liver failure. Because of the importance of pharmacotherapy of epilepsy, the potential hepatotoxicity of these agents has been considered acceptable. Nevertheless, attempts at developing safer agents of equivalent or superior efficacy continue.

Major anticonvulsants include hydantoin derivatives, barbiturates, benzodiazepines, succinimides, valproic acid, gamma amino butyric acid (GABA) precursors and analogues, inhibitors of DMDA receptors and a multitude of miscellaneous recently introduced agents. At least two dozen agents are licensed and approved for use as anticonvulsants in the United States. The anticonvulsants that are available in the United States, the likelihood score for hepatotoxicity, their year of introduction or approval and their major approved indications are shown in the Table which includes links to the individual agents with the full description and discussion of their potential for hepatotoxicity.

Phenobarbital is the oldest antiepileptic medication still in use, having been introduced into clinical medicine in 1916. Phenobarbital is an aromatic anticonvulsant and, like phenytoin and carbamazepine, can cause the aromatic anticonvulsant hypersensitivity syndrome, a form of drug reaction with eosinophilia and systemic symptoms (DRESS) syndrome. Questions remain regarding the anticonvulsant efficacy of phenobarbital and it is now rarely used for this indication.

Phenytoin, formerly known as diphenylhydantoin, was introduced into use as an anticonvulsant in 1938 and remains one of the most commonly used medications for epilepsy. Fosphenytoin is an intravenous formulation of phenytoin that has been available since 1995 and is used for status epilepticus and as a substitute for oral phenytoin during surgery. Phenytoin is a well known cause of acute liver injury, which is usually part of the anticonvulsant hypersensitivity syndrome and can be severe and lead to acute liver failure and death.

Carbamazepine was introduced into use in 1963 for treatment of generalized seizures and with other carbamazepines (oxcarbazepine, eliscarbazepine) is still widely used. Carbamazepine can also cause the anticonvulsant hypersensitivity syndrome and is a well known cause of acute drug induced liver injury as well as serious cutaneous reactions such as Stevens-Johnson syndrome and toxic epidermal necrolysis.

Lamotrigine is a more recently developed anticonvulsant that has broad antiseizure activity. Lamotrigine can also cause the anticonvulsant hypersensitivity syndrome and has become one of the most common causes of clinically apparent drug-induced liver injury.

The benzodiazepines are both anxiolytic and antiepileptic and several including diazepam, clonazepam and clorazepate are used in the therapy of epilepsy. Benzodiazepines are also discussed under the antianxiolytic medications. They appear to act by enhancing gamma aminobutyric acid (GABA) receptor activity. While many benzodiazepines have antiseizure activity, only clonazepam and clorazepate are commonly used in long term treatment of epilepsy. Diazepam and other parentally administered benzodiazepams are also used for therapy of status epilepticus. Benzodiazepines have only rarely been implicated in causing drug induced liver injury and have not been implicated in the anticonvulsant hypersensitivity syndrome.

The succinimides are active against clonic motor seizures and absence seizures (petit mal) in humans. This class includes ethosuximide (1960) and methsuximide (1957).

Valproic acid or valproate is a branched chain carboxylic acid that was found to have antiseizure activity somewhat by accident. Valproate was introduced in 1978 and rapidly became a commonly used agent for partial seizures and for poorly controlled generalized seizures. Valproic acid is also used in the treatment of mood and bipolar disorders. Valproate can cause several distinctive forms of liver injury, ranging from asymptomatic serum aminotransferase elevations to an acute hepatitis which can be severe and even fatal, to a Reye syndrome like syndrome of hepatic dysfunction and microvesicular fatty liver. High doses of valproic acid can also cause stupor and coma from hyperammonemia without accompanying severe liver injury.

Topiramate is a sulfamate-substituted monosaccharide and unique and broadly active anticonvulsant introduced in 1996 that is still widely used. Topiramate is also used for prevention of migraine headaches, as a weight loss agent and (off label) for mood disorders and bipolar illness.

Levetiracetam is a pyrrolidine derivative and unique anticonvulsant introduced in 1999 that has been increasing used because of its safety and excellent tolerability. Levetiracetam binds to the synaptic vesicle glycoprotein SV2A and appears to act by inhibiting calcium channels which participate in neurotransmitter release. Levetiracetam has been linked to rare instances of drug induced liver disease, but not with the anticonvulsant hypersensitivity syndrome. Brivaracetam is an anticonvulsant of similar structure and activity was approved in 2016.

Other agents active against seizures have been developed in recent years, many of which act by uncertain mechanisms and which belong to different classes of agents. These agents, their likelihood score, year of approval and major indications are given below.

ANTICONVULSANTS*
Generic Name Brand Name | Likelihood Score | Approval | Major Indications
Brivaracetam Briviact | E | 2016 | Partial seizures
Cannabidiol Epidiolex | E* | 2018 | Seizures associated with Lennox-Gastaut or Dravet syndrome
Carbamazepine Tegretol | A | 1968 | Partial, mixed and generalized seizures, trigeminal neuralgia
Cenobamate Xcopri | D | 2020 | Partial seizures
Clobazam Onfi | E | 2011 | Seizures associated with Lennox-Gastaut syndrome
Clonazepam Klonopin | D | 1975 | Absence and myoclonic seizures, anxiety and panic disorders
Clorazepate Tranxene | E | 1972 | Partial seizures, anxiety disorders, and alcohol withdrawal
Diazepam Valium | E | 1963 | Convulsions, anxiety disorders, muscle spasms
Eslicarbazepine Aptiom | D | 2013 | Partial seizures
Ethosuximide Zarontin | E | 1960 | Absence seizures
Ezogabine Potiga | E | 2011 | Partial seizures
Felbamate Febatol | B | 1993 | Refractory or severe epilepsy
Fosphenytoin Cerebyx | A | 1996 | Tonic-clonic seizures, status epilepticus
Gabapentin Neurontin | C | 1993 | Partial seizures, post-herpetic neuralgia
Lacosamide Vimpat | D | 2008 | Partial seizures
Lamotrigine Lamictal | A | 1994 | Partial and generalized tonic-clonic seizures, bipolar disorder
Levetiracetam Keppra | C | 1999 | Partial, generalized tonic-clonic, and myoclonic seizures
Methsuximide Celontin | E | 1957 | Absence seizures
Oxcarbazepine Trileptal | D | 2000 | Partial seizures
Perampanel Fycompa | E | 2012 | Partial and generalized tonic-clonic seizures
Phenobarbital Luminal | B | 1916 | Partial and generalized seizures, anxiety, and irritable bowel syndrome
Phenytoin Dilantin | A | 1938 | Generalized tonic-clonic and partial onset seizures, status epilepticus
Pregabalin Lyrica | C | 2004 | Partial seizures, fibromyalgia, and neuropathic pain
Primidone Mysoline | E* | 1954 | Partial and generalized tonic-clonic seizures
Rufinamide Banzel | E* | 2008 | Seizures associated with Dravet syndrome
Stiripentol Diacomit | E | 2018 | Seizures associated with Dravet syndrome
Tiagabine Gabitril | E | 1997 | Partial seizures
Topiramate Topamax | C | 1996 | Partial and generalized tonic-clonic seizures, migraine headaches
Valproate Depakene | A | 1978 | Absence and complex partial seizures
Vigabatrin Sabril | D | 2009 | Refractory, complex partial seizures, and infantile spasms
Zonisamide Zonegran | D | 2000 | Partial seizures

* Underlined Name indicates the availability of a LiverTox record.

## ANNOTATED BIBLIOGRAPHY

References updated: 18 April 2019

Zimmerman HJ. Anticonvulsants. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 498-516. (Expert review of anticonvulsants and liver injury published in 1999).
Pirmohamed M, Leeder SJ. Anticonvulsant agents. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013: pp 423-42. (Review of anticonvulsant induced liver injury).
Smith MD, Metcalf CS, Wilcox KS. Pharmacotherapy of the epilepsies. In, Brunton LL, Hilal-Dandan R, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 303-26. (Textbook of pharmacology and therapeutics).
Wallace SJ. (1996). A comparative review of the adverse effects of anticonvulsants in children with epilepsy. Drug Saf. (Systematic review; ALT elevations occur in 4% of children on phenytoin, 6% on valproate, 1% on carbamazepine and rarely with tiagabine or gabapentin; no mention of hepatotoxicity of topiramate).
Hamer HM, Morris HH. (1999). Hypersensitivity syndrome to antiepileptic drugs: a review including new anticonvulsants. Cleve Clin J Med. (Clinical review: hypersensitivity occurs in 1 to 5 per 10,000 users with a higher risk in African Americans and affected siblings; liver involvement common, but most cases are anicteric; other manifestations include facial edema, lymphadenopathy, bone marrow aplasia, pseudolymphoma, thyroiditis, interstitial nephritis; switching to valproate and benzodiazepines is safe, levetiracetam is also an option).
Wilby J, Kainth A, Hawkins N, Epstein D, McIntosh H, McDaid C, Mason A, et al. (2005). Clinical effectiveness, tolerability and cost-effectiveness of newer drugs for epilepsy in adults: a systematic review and economic evaluation. Health Technol Assess. (Extensive systematic review of anticonvulsant medications including assessment of serious, rare and long term adverse events; focusing on gabapentin, lamotrigine, oxcarbazepine, tiagabine, topiramate and vigabatrin).
LaRoche SM. (2007). A new look at the second-generation antiepileptic drugs: a decade of experience. Neurologist. (Review of second generation anticonvulsants approved since 1994 including felbamate, gabapentin, lamotrigine, pregabalin, topiramate, tiagabine, levetiracetam, oxcarbazepine and zonisamide; Stevens-Johnson syndrome is associated with lamotrigine and oxcarbazepine, no mention of liver toxicity from the other agents).
Chalasani N, Fontana RJ, Bonkovsky HL, Watkins PB, Davern T, Serrano J, Yang H, Rochon J, Drug Induced Liver Injury Network (DILIN). (2008). Causes, clinical features, and outcomes from a prospective study of drug-induced liver injury in the United States. Gastroenterology. (Among 300 cases of drug induced liver disease in the US collected between 2004 and 2008, valproate accounted for 6, lamotrigine 5, phenytoin 5, gabapentin and topiramate 1 each, but details not provided).
Björnsson E. (2008). Hepatotoxicity associated with antiepileptic drugs. Acta Neurol Scand. (Review of anticonvulsant induced liver injury).
Reuben A, Koch DG, Lee WM, Acute Liver Failure Study Group. (2010). Drug-induced acute liver failure: results of a U.S. multicenter, prospective study. Hepatology. (Among 1198 patients with acute liver failure enrolled in a US prospective study between 1998 and 2007, 133 were attributed to drug induced liver injury including 13 [10%] due to anticonvulsants: phenytoin 8, carbamazepine 3 and valproate 2).
Ferrajolo C, Capuano A, Verhamme KM, Schuemie M, Rossi F, Stricker BH, Sturkenboom MC. (2010). Drug-induced hepatic injury in children: a case/non-case study of suspected adverse drug reactions in VigiBase. Br J Clin Pharmacol. (Worldwide pharmacovigilance database contained 9036 hepatic adverse drug reactions in children, 7 anticonvulsants were listed among the top 41 causes: valproate [208 cases, ranking 3rd] carbamazepine [140, 4th], lamotrigine [112, 7th], phenytoin [57, 20th], topiramate [51, 22nd], oxcarbazepine [43, 28th], phenobarbital [41, 32nd]).
Devarbhavi H, Karanth D, Prasanna KS, Adarsh CK, Patil M. (2011). Drug-Induced liver injury with hypersensitivity features has a better outcome: a single-center experience of 39 children and adolescents. Hepatology. (Among 39 children with drug induced liver disease seen at a single referral center in India between 2005 and 2010, 10 cases were due to phenytoin and 6 to carbamazepine, all of whom survived in contrast to deaths of 12 of 23 children with hepatocellular injury without signs of hypersensitivity [largely due to antituberculosis medications]).
Molleston JP, Fontana RJ, Lopez MJ, Kleiner DE, Gu J, Chalasani N, Drug-Induced Liver Injury Network. (2011). Characteristics of idiosyncratic drug-induced liver injury in children: results from the DILIN Prospective Study. J Pediatr Gastroenterol Nutr. (Among 30 children with drug induced liver injury enrolled in a prospective US database between 2004 and 2008, 8 were due to anticonvulsants [lamotrigine in 3, valproate in 3, phenytoin in 1 and carbamazepine in 1], none of which were fatal or led to chronic injury).
Kwon H, Lee SH, Kim SE, Lee JH, Jee YK, Kang HR, Park BJ, Park JW, Hong CS. (2012). Spontaneously reported hepatic adverse drug events in Korea: multicenter study. J Korean Med Sci. (Summary of 2 years of adverse event reporting in Korea; of 9360 reports, 567 were liver related, including 55 [10%] attributed to anticonvulsants: 33 to valproate, 8 topiramate, 6 carbamazepine, 2 lamotrigine, 2 gabapentin and 1 phenytoin).
(2013). Drugs for epilepsy. Treat Guidel Med Lett. (Concise review of drugs of choice for epilepsy with discussion of clinical indications, adverse effects).
Björnsson ES, Bergmann OM, Björnsson HK, Kvaran RB, Olafsson S. (2013). Incidence, presentation and outcomes in patients with drug-induced liver injury in the general population of Iceland. Gastroenterology. (In a population based study of drug induced liver injury from Iceland, 96 cases were identified over a 2 year period, including 3 attributed to anticonvulsants: 2 due to phenytoin and 1 to gabapentin).
Hernández N, Bessone F, Sánchez A, di Pace M, Brahm J, Zapata R, A, Chirino R, et al. (2014). Profile of idiosyncratic drug induced liver injury in Latin America. An analysis of published reports. Ann Hepatol. (Systematic review of literature of drug induced liver injury in Latin American countries published from 1996 to 2012 identified 176 cases, 7 of which were due to anticonvulsants: 3 due to valproate, 3 phenytoin and 1 carbamazepine).
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al., United States Drug Induced Liver Injury Network. (2015). Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, 40 [4.5%] were attributed to anticonvulsant agents including 12 to phenytoin, 9 lamotrigine, 7 valproic acid, 4 carbamazepine, 3 gabapentin, 2 topiramate, 1 pregabalin, 1 ethosuximide, and 1 fosphenytoin).
(2017). Drugs for epilepsy. Med Lett Drugs Ther. (Concise review of the drugs available for therapy of epilepsy including brief summary of adverse events with each).
Vidaurre J, Gedela S, Yarosz S. (2017). Antiepileptic drugs and liver disease. Pediatr Neurol. (Review of the use of anticonvulsants in patients with liver disease recommends use of agents that have little hepatic metabolism such as levetiracetam, lacosamide, topiramate, gabapentin and pregabalin, lacosamide being a good choice because of linear pharmacokinetics, only partial hepatic metabolism, with inactive metabolites and lack of clinically significant CYP450 interactions).